# Omega-3 Fatty Acids

## OVERVIEW

### Introduction

Omega-3 fatty acids are essential polyunsaturated fatty acids that have diverse functions in normal metabolism and health and are used as nutritional supplements for general health and for disease prevention and as prescription drugs for treatment of hypertriglyceridemia. The omega-3 fatty acids are generally safe and well tolerated and have not been implicated in causing serum enzyme elevations or clinically apparent liver injury.

### Background

The omega-3 fatty acids are essential fatty acids that serve several important functions in normal metabolism and health. Omega-3 refers to their common structural feature of an unsaturated double bond at the third carbon bond from the “omega” end of the long chain fatty acid (n-3). There are three essential omega-3 fatty acids: alpha-linolenic acid (ALA), eicosapentaenoic acid (EPA), and docosahexaenoic acid (DHA). ALA is an 18-carbon fatty acid with 3 double bonds (18:3n-3) and is found in plant oils such as walnut, flaxseed and canola oil. EPA, a 21-carbon molecule with 5 double bonds (21:5n-3), and DHA, a 22-carbon molecule with 6 double bonds (22:6n-3), are found in marine oils such as fish oils, squid oils and krill oil. Being essential, these fatty acids are not (or poorly) synthesized by humans and the necessary amounts must be provided in the diet. The amounts of omega-3 fatty acids in a typical Western diet can be marginal or inadequate, particularly EPA and DHA in persons with limited fish intake. For these reasons, the omega-3 fatty acids are some of the most commonly used nutrition supplements. They have been proposed to be not only necessary for good health, but also to be effective in prevention of many chronic conditions, including different forms of cancer, coronary artery disease, cerebrovascular disease, developmental disabilities, depression, bipolar illness, cognitive decline, Alzheimer disease, macular degeneration, rheumatoid arthritis, eczema and allergic conditions. However, efficacy of omega-3 fatty acid supplementation in any of these conditions has not been proven and results of prospective controlled trials have been largely negative or at most conflicting. Nevertheless, omega-3 fatty acids are popular nutritional supplements and hundreds of products are available under many commercial names such as “GNC Krill Oil”, “Nordic Natural DHA”, “Carlson Fish Oil Q”, “iHealth Overga-3”, “Jarrow Formulas Flaxseed Oil”, “ProThera Eicosamax Fish”, and “Swanson EFAs”, among others. These products are usually in the form of capsules and vary widely in concentration of the individual omega-3 fatty acids, but are generally in the range of 250 mg to 1,000 mg of total omega-3 fatty acids and recommended as being taken once daily. Side effects of omega-3 fatty acid and fish oil supplements in these doses are minimal, but may include mild gastrointestinal discomfort, nausea, diarrhea and headache. More clinically significant side effects include platelet dysfunction and an increased risk of bleeding, particularly in patients on anticoagulant and antithrombotic therapy.

### Hepatotoxicity

In the many, large, randomized controlled trials of the omega-3 fatty acids, side effects have been minimal. Use of omega-3 fatty acids even in high doses has not been linked convincingly to serum enzyme elevations or to instances of clinically apparent liver injury. At high doses used to treat hypertriglyceridemia, minor ALT elevations were identified in up to 12% of patients, but similar rates occurred in placebo treated subjects and the abnormalities were transient, mild and not associated with symptoms or jaundice. Indeed, there have been several clinical trials of various formulations of the omega-3 fatty acids in patients with nonalcoholic fatty liver and preexisting elevations in serum aminotransferase levels. While not demonstrating a convincing beneficial effect in fatty liver disease, the omega-3 fatty acids also did not demonstrate any evidence of hepatic injury or worsening of the preexisting serum enzyme elevations.

Likelihood score: E (unlikely cause of clinically apparent liver injury).

### Mechanism of Injury

Omega-3 fatty acids are metabolized in the liver by beta-oxidation and broken down locally, usually into short chain fatty acids. They have little effect on hepatic cytochrome P450 or drug transporter activity. Their effects on triglyceride metabolism are more likely to be beneficial than harmful to hepatocytes.

### Prescription Omega-3 Fatty Acid Preparations

In addition to their use in nutritional supplements, omega-3 fatty acids have been developed as therapies of dyslipidemia and approved as prescription drugs or “medical foods” under the ingredient names omega-3 acid ethyl esters (Lovaza 2004, and generics), icosapent ethyl (Vascepa 2012), and omega-3 carboxylic acids (Epanova 2014). When used to lower triglyceride levels, omega-3 fatty acids are taken in high doses, between 2 and 4 grams daily. These omega-3 fatty acid derivatives are approved as adjunctive therapy of severe hypertriglyceridemia to be used in combination with diet with or without other lipid lowering medications. The mechanism of action of the omega-3 fatty acids in reducing triglyceride levels is not clearly defined, but appears to be inhibition of synthesis of triglycerides in the liver and their accelerated degradation, perhaps through increased plasma lipoprotein lipase activity. These three omega-3 fatty acid derivatives are discussed individually below.

### Omega-3 Acid Ethyl Esters

Lovaza (previously known as Omacor) consists of a mixture of omega-3 fatty acid ethyl esters that have been purified from fish oil. The major fatty acid constituents are EPA and DHA, but other long-chain polyunsaturated fatty acid esters are also present in lower concentrations. The starting oil is screened for heavy metal or polychlorinated biphenyl (PCB) contamination and the pooled product purified and esterified to give the final product stability. In preregistration trials in patients with severe hypertriglyceridemia (above 500 mg/dL), Lovaza in doses of 4 grams daily was associated with a 45% decrease in serum triglycerides in comparison to no change or a slight increase with placebo. Therapy was also associated with mild-to-moderate increases low density lipoprotein (LDL) cholesterol. A major complication and reason for treating hypertriglyceridemia is acute pancreatitis, but rates of attacks of pancreatitis could not be evaluated in these trials because of the limited sample size and treatment duration. Lovaza was approved for use in the United States in 2004. Several generic forms are now available, usually as 1 gram capsules. The recommended dose is 4 g daily (in one or two divided doses). Side effects are uncommon and generally mild, but can include dyspepsia, diarrhea, nausea, eructation and unpleasant aftertaste. Potentially more severe adverse events include an increased risk of bleeding, particularly if taken with other anticoagulants or antiplatelet agents.

In preregistration clinical trials, omega-3 acid ethyl esters were associated with uncommon and mild increases in serum ALT levels without changes in alkaline phosphatase or bilirubin levels. These abnormalities were asymptomatic and transient, but led to a recommendation of monitoring routine liver tests periodically during therapy with Lovaza. Since approval and wide scale use of this product, however, there have been no reports of liver injury attributable to the omega-3 acid esters and subsequent trials of these products have not mentioned serum aminotransferase elevations or hepatotoxicity in discussions of adverse events. The product label now recommends monitoring ALT and AST levels periodically only in patients with preexisting hepatic impairment, a recommendation added to product labels of all prescription omega-3 fatty acids.

Likelihood score: E (unlikely cause of clinically apparent liver injury).

### Icosapent Ethyl

Vascepa is the commercial name for icosapent (eye koe’ sa pent) ethyl, an ethyl ester of eicosapentaenoic acid (EPA) extracted and purified from fish oil. During absorption, icosapent is de-esterified to the active EPA molecule. In preregistration trials, icosapent in doses of 4 grams daily lowered serum triglyceride levels by 27% in patients with severe hypertriglyceridemia (above 500 mg/dL) compared to minor increases with placebo. Rates of pancreatitis could not be evaluated in these trials because of the limited sample size and treatment duration. In contrast to omega-3 fatty acid ethyl esters, icosapent had little effect on serum total or LDL cholesterol levels, perhaps because it consists of modified EPA only without DHA. Vascepa was approved for use in the United Sates in 2012. It is available in 1 gram capsules and the recommended dose is 2 g twice daily. Side effects are uncommon and generally mild, but can include arthralgia, diarrhea, nausea, abdominal pain and eructation. Potential severe adverse events include an increased risk of bleeding, particularly if taken with other anticoagulants or antiplatelet agents.

In preregistration clinical trials in patients with hypertriglyceridemia, liver test abnormalities were no more frequent among patients receiving icosapent than in those on placebo, and there were no reports of clinically apparent liver injury. In a pooled analysis of studies, mild elevations in ALT (up to 2 times the upper limit of normal) occurred in 12.8% of icosapent- compared to 10.3% of placebo treated subjects. However, no patient developed jaundice or symptoms and the abnormalities apparently resolved without dose adjustment. Since its approval and more widespread clinical use, there have been no published reports of hepatotoxicity attributable to icosapent. Nevertheless, the product labels of all prescription omega-3 fatty acid products recommend monitoring aminotransferase levels in patients with preexisting hepatic impairment.

Likelihood score: E (unlikely cause of clinically apparent liver injury).

### Omega-3 Carboxylic Acids

Epanova is the commercial name of a fish oil extract and mixture of omega-3 carboxylic acids, predominantly derivatives of EPA and DPA. In preregistration clinical trials, Epanova in a dose of 4 g daily lowered serum triglyceride levels by 31% in patients with severe hypertriglyceridemia (above 500 mg/dL) compared to minor changes with placebo. Rates of pancreatitis could not be evaluated in these trials because of the limited sample size and treatment duration. Similar to omega-3 fatty acid ethyl esters, omega-3 carboxylic acid treatment was associated with mild-to-moderate increases in LDL cholesterol levels. Epanova was approved for use in the United Sates in 2014 and is available in 1 gram capsules; the recommended dose being 2 or 4 g once daily. Side effects are generally mild, but can include diarrhea, nausea, abdominal pain and eructation. Potential severe adverse events include an increased risk of bleeding, particularly if taken with other anticoagulants or antiplatelet agents.

In preregistration clinical trials in patients with hypertriglyceridemia, liver test abnormalities were no more frequent among patients receiving omega-3 carboxylic acids than in those on placebo, and there were no reports of clinically apparent liver injury. In a pooled analysis of studies, mild elevations in ALT (up to 2 times the upper limit of normal) occurred in less than 1% of omega-3 carboxylic acid treated subjects and a similar proportion of those on placebo. There were no elevations above 5 times the upper limit of normal and no patient developed jaundice or symptoms and the abnormalities apparently resolved without dose adjustment. Since its approval and more widespread clinical use, there have been no published reports of hepatotoxicity attributable to Epanova. Nevertheless, the product labels of all prescription omega-3 fatty acid products recommend monitoring aminotransferase levels in patients with pre-existing hepatic impairment.

Likelihood score: E (unlikely cause of clinically apparent liver injury).

Drug Class: Herbals and Botanical Supplements, Nutritional Supplements; Antilipemic Agents

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Omega-3 Fatty Acids – Generic®

Omega-3 Acid Ethyl Esters – Generic, Lovaza®

Icosapent Ethyl – Vascepa®

Omega-3 Carboxylic Acids – Epanova®

DRUG CLASS

Herbal and Botanical Supplements

COMPLETE LABELING

Fact Sheet at National Center for Complementary and Integrative Health, NIH (https://nccih.nih.gov/health/omega3)

Fact Sheet at Office of Dietary Supplements, NIH (https://medlineplus.gov/druginfo/meds/a607065.html)

## CHEMICAL FORMULAS AND STRUCTURES

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
ALA | 463-40-1 | C18-H30-O2 | ALA Chemical Structure
EPA | 1553-41-9 | C20-H30-O2 | EPA Chemical Structure
DHA | 25167-62-8 | C22-H32-O2 | DHA Chemical Structure

## ANNOTATED BIBLIOGRAPHY

References updated: 08 April 2017

Abbreviations used: EPA, eicosapentaenoic acid; DHA, docosahexaenoic acid.

Zimmerman HJ. Unconventional drugs. Miscellaneous drugs and diagnostic chemicals. In, Zimmerman, HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott,1999: pp. 731-4. (Expert review of hepatotoxicity published in 1999; the omega-3 fatty acids are not discussed).
Jones PJH, Kubow S. Lipids, steroids, and their metabolites. In, Shils ME, Olson JA, Shike M, Ross AC, eds. Modern nutrition in health and disease. 9th ed. Baltimore: Williams & Wilkins, 1998; pp. 6794. (Textbook of nutrition).
Harris WS, Ginsberg HN, Arunakul N, Shachter NS, Windsor SL, Adams M, Berglund L, Osmundsen K. Safety and efficacy of Omacor in severe hypertriglyceridemia. J Cardiovasc Risk 1997; 4 (5-6): 385-91. (Among 42 patients with hypertriglyceridemia treated with omega-3 acid ethyl esters [4 g daily] or placebo for 4 months, triglyceride levels decreased by 45% with omega-3 fatty acid therapy vs no effect of placebo and there were no severe adverse events or discontinuations, and therapy had “no impact on any of the safety panel parameters measured, including…liver enzymes”). 9865671
Durrington PN, Bhatnagar D, Mackness MI, Morgan J, Julier K, Khan MA, France M. An omega-3 polyunsaturated fatty acid concentrate administered for one year decreased triglycerides in simvastatin treated patients with coronary heart disease and persisting hypertriglyceridaemia. Heart 2001; 85: 544-8. (Among 59 patients with hypertriglyceridemia on long term therapy with simvastatin and persistent triglyceride elevations who were treated with omega-3 fatty acids [4 g daily] or placebo for 24 weeks, triglycerides decreased by 30-40% and “there were no apparent differences” between the two groups “in the frequency of laboratory values outside the reference range”). 11303007
Omega-3 polyunsaturated fatty acids(Omacor) for hypertriglyceridemia. Med Lett Drugs Ther 2005; 47 (1221): 91. (Concise review of mechanism of action, clinical efficacy, adverse effects and costs of omega-3 fatty acid ethyl esters shortly after their approval for use in hypertriglyceridemia; no mention of ALT elevations or hepatotoxicity). 16267495
Feagan BG, Sandborn WJ, Mittmann U, Bar-Meir S, D'Haens G, Bradette M, Cohen A, et al. Omega-3 free fatty acids for the maintenance of remission in Crohn disease: the EPIC Randomized Controlled Trials. JAMA 2008; 299: 1690-7. (Among 753 patients with Crohn disease in remission treated with omega-3 carboxylic acids [4 g daily] or placebo in two controlled trials, the 1 year relapse rates were similar in both treatment groups in both studies and adverse events were uncommon, those more frequent with Epanova being nausea, diarrhea and dysgeusia, and there were “no differences in laboratory results” identified except for lower triglycerides in omega-3 fatty acid treated subjects). 18398081
Kowey PR, Reiffel JA, Ellenbogen KA, Naccarelli GV, Pratt CM. Efficacy and safety of prescription omega-3 fatty acids for the prevention of recurrent symptomatic atrial fibrillation: a randomized controlled trial. JAMA 2010; 304: 2363-72. (Among 663 patients with recurrent atrial fibrillation treated with omega-3 fatty acids [4 g daily] or placebo for 24 weeks, rates of atrial fibrillation recurrence were similar in the 2 groups as were adverse event rates including “abnormal liver tests” [<1% in both groups]). 21078810
Bays HE, Ballantyne CM, Kastelein JJ, Isaacsohn JL, Braeckman RA, Soni PN. Eicosapentaenoic acid ethyl ester (AMR101) therapy in patients with very high triglyceride levels(from the Multi-center, plAcebo-controlled, Randomized, double-blINd, 12-week study with an open-label Extension [MARINE] trial). Am J Cardiol 2011; 108: 682-90. (Among 229 patients with hypertriglyceridemia [>500 mg/dL] treated with icosapent [2 g or 4 g daily] or placebo for 12 weeks, serum triglyceride levels decreased by 20-33% on icosapent vs no change on placebo, while adverse event rates were similar in all groups and neither dose of icosapent produced significant changes in aminotransferase levels). 21683321
Ballantyne CM, Bays HE, Kastelein JJ, Stein E, Isaacsohn JL, Braeckman RA, Soni PN. Efficacy and safety of eicosapentaenoic acid ethyl ester (AMR101) therapy in statin-treated patients with persistent high triglycerides (from the ANCHOR study). Am J Cardiol 2012; 110 984-92. (Among 702 patients on statins with persistent triglyceride elevations [200-500 mg/dL] treated with icosapent [2 or 4 g daily] or placebo for 12 weeks, triglyceride levels decreased by 10-22% with icosapent and rates of adverse events were similar in all treatment groups, and no “clinically significant increases” in ALT or AST occurred in icosapent treated groups). 22819432
Fish oil supplements. Med Lett Drugs Ther 2012; 54 (1401): 83-4. (Concise review of 2 omega-3 fatty acid preparations approved as treatment for severe hypertriglyceridemia, Omacor [Lovaza] and Vascepa; mentions adverse events of dyspepsia, eructation and unpleasant aftertaste, but does not mention ALT elevations or hepatotoxicity). 23059421
Risk and Prevention Study Collaborative Group, Roncaglioni MC, Tombesi M, Avanzini F, Barlera S, Caimi V, Longoni P, Marzona I, et al. n-3 fatty acids in patients with multiple cardiovascular risk factors. N Engl J Med 2013; 368: 1800-8. (Among 12,513 adults with cardiovascular risk factors treated with omega-3 fatty acids or placebo daily for a median of 5 years, there were no significant differences in rates of cardiovascular endpoints or death nor in adverse event rates; no mention of ALT levels or hepatotoxicity). 23656645
Age-Related Eye Disease Study 2 Research Group. Lutein + zeaxanthin and omega-3 fatty acids for age-related macular degeneration: the Age-Related Eye Disease Study 2 (AREDS2) randomized clinical trial. JAMA 2013; 309: 2005-15. (Among 4203 adults [ages 50 year or older] treated with omega-3 fatty acids or lutein with zeaxanthin or both or placebo for a median of 5 years, there were no differences in rates of macular degeneration among treatment groups and adverse event rate were similar; no mention of ALT elevations or hepatotoxicity). 23644932
Icosapent ethyl (Vascepa) for severe hypertriglyceridemia. Med Lett Drugs Ther 2013; 55 (1415): 33-4. (Concise review of the mechanism of action, clinical efficacy, safety and costs of icosapent ethyl shortly after its approval in the US for treatment of severe hypertriglyceridemia; mentions minor side effects, but not ALT elevations or hepatotoxicity). 23836343
Drugs for hypertriglyceridemia. Med Lett Drugs Ther 2013; 55 (1411): 17-9. (Concise review of drugs approved for therapy of hypertriglyceridemia including fibrates, niacin and fish oil; mentions risk of liver injury with fibrates and niacin, but not fish oils or omega-3 fatty acids). 23467119
Kastelein JJ, Maki KC, Susekov A, Ezhov M, Nordestgaard BG, Machielse BN, Kling D, et al. Lowering Very high triglyceridEs (EVOLVE) trial. J Clin Lipidol 2014; 8: 94-106. (Among 399 patients with hypertriglyceridemia [>500 mg/dL] treated with Epanova [2, 3 or 4 g daily] or olive oil for 12 weeks, fasting triglyceride levels decreased by 26-31% with omega-3 carboxylic acids vs 4% on olive oil, and adverse events more common with the omega-3 fatty acids included diarrhea [6-10% vs 25], abdominal discomfort [1-4% vs 1%], nausea [5-9% vs 1%] and eructation [3-4% vs 1%]; no mention of ALT elevations or hepatotoxicity). 24528690
Sanyal AJ, Abdelmalek MF, Suzuki A, Cummings OW, Chojkier M; EPE-A Study Group. No significant effects of ethyl-eicosapentanoic acid on histologic features of nonalcoholic steatohepatitis in a phase 2 trial. Gastroenterology 2014; 147: 377-84. e1. (Among 243 adults with NAFLD treated with ethyl-eicosapentanoic acid [1800 or 2700 mg] or placebo daily for 12 months, improvements in serum triglycerides but not liver histology or ALT levels were greater among the omega-3 fatty acid treated groups and “there were no significant differences in the rates of any specific or overall adverse events across the study arms”). 24818764
Writing Group for the AREDS2 Research Group., Bonds DE, Harrington M, Worrall BB, Bertoni AG, Eaton CB, Hsia J, Robinson J, et al. Effect of long-chain ω-3 fatty acids and lutein + zeaxanthin supplements on cardiovascular outcomes: results of the Age-Related Eye Disease Study 2 (AREDS2) randomized clinical trial. JAMA Intern Med 2014; 174: 763-71. (Among 4203 participants in the AREDS2 clinical trial who were treated with omega-3 fatty acids, xanthophylls (or both) or placebo for a median of 4.8 years, there were no differences in rates of cardiovascular outcomes or death or of adverse events by treatment group; no mention of ALT levels and hepatotoxicity). 24638908
Scorletti E, Bhatia L, McCormick KG, Clough GF, Nash K, Hodson L, Moyses HE, et al.; WELCOME Study. Effects of purified eicosapentaenoic and docosahexaenoic acids in nonalcoholic fatty liver disease: results from the Welcome* study. Hepatology 2014; 60: 1211-21. (Among 103 patients with NAFLD treated with omega-3 fatty acids [4 g daily] or placebo for 15-18 months, there were no significant differences in changes in ALT, AST, and liver or visceral fat between the two groups; no mention of adverse events). 25043514
Weintraub HS. Overview of prescription omega-3 fatty acid products for hypertriglyceridemia. Postgrad Med 2014; 126: 7-18. (Summary of the three forms of prescription omega-3 fatty acids approved in the US as therapy for severe hypertriglyceridemia). 25387209
Su TC, Hwang JJ, Huang KC, Chiang FT, Chien KL, Wang KY, Charng MJ, et al. A randomized, double-blind, placebo-controlled clinical trial to assess the efficacy and safety of ethyl-ester omega-3 fatty acid in Taiwanese hypertriglyceridemic patients. J Atheroscler Thromb 2017; 24: 275-89. (Among 253 Taiwanese adults with high triglyceride levels [200-1000 mg/dL] treated with omega-3 acid ethyl esters [4 g daily] vs placebo for 8 weeks, triglyceride levels decreased by 30% vs 5%, while adverse events were uncommon and similar between treatment groups; no mention of ALT elevations or hepatotoxicity). 27600795

## OTHER REFERENCE LINKS

1. Recent References on Omega-3 Fatty Acids: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Omega-3+Fatty+Acids/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. Trials on Omega-3 Fatty Acids: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Omega-3)